# Master List of LiverTox Drugs

## Description

The Master List of LiverTox Drugs is a Microsoft Excel spreadsheet that lists all drugs or agents that are in LiverTox [or are meant to be added in the future] with supporting metadata. Excel provides the ability to manipulate the data such as sorting by type of agent, year of approval or classification, and making counts and calculations that are automatic. For example, the user can sort all drugs by likelihood score or list all antineoplastic (anticancer) drugs. This file and its content are not copyrighted and can be used in data analyses, publications or presentations. Attribution of its use is not required but is always appreciated. The Master List is updated yearly. Approximately 50 new agents are added each year and between 50 and 150 are updated.

The Master List of LiverTox Drugs can be accessed here.

The Master List is arranged alphabetically and provides the following data.

- Ingredient: The generic name of the drug/agent.
- Brand Name: A common or representative brand name of the drug.
- Likelihood Score: The likelihood that the drug is associated with liver injury.
- Chapter Title: The title of the chapter that describes the drug; this may be specificfor the drug or the drug class chapter that includes descriptions of multiple drugs.
- Last Update: The date when the chapter and/or references were last revised.
- Number of References: The total number of all references within the chapter.
- Year Approved: The year in which the drug was first approved in the United States.
- Type of Agent: P, prescription or conventional drug; PP, prescription drug in combination, or, in an overview or drug class chapter; H, herbal product; I, Illicit agent; M, mineral; MIDS, multi-ingredient dietary supplement; N, nutritional supplement.
- In LiverTox: Whether the drug or agent is described in LiverTox: 1=yes; 0=no.
- Primary Classification: Principal organ system involved with use of the drug.
- Secondary Classification: Major indication or disease treated with the drug.